# Ivermectin

## OVERVIEW

### Introduction

Ivermectin is an antiinfective agent with activity against several parasitic nematodes and scabies and is the treatment of choice for onchocerciasis (river blindness). It is typically given as one or two oral doses. Ivermectin therapy has been associated with minor, self-limiting serum aminotransferase elevations and very rare instances of clinically apparent liver injury.

### Background

Ivermectin (eye" ver mek" tin) is a macrocyclic lactone and semisynthetic derivative of avermectin which is produced by Streptomyces avermitilis. Ivermectin has potent activity against several parasites and arthropods. It believed to act by interference with a glutamate gated chloride channel, which interferes with the parasite's neural and neuromuscular transmission. It has a broad spectrum of activity against several nematodes (Ascaris, Trichuris, Ancylostoma), cestodes (Taenia) and trematodes (Fasciola, Schistosoma). Ivermectin has particularly potent activity against onchocerciasis (river blindness) and lymphatic filariasis, which are important endemic diseases in Africa and South America. Ivermectin was approved for use in the United States in 1996 for strongyloidiasis and onchocerciasis. In other countries it is also approved for use in scabies, lice infestation and ascariasis. Ivermectin is available in tablets of 3 mg under the brand name Stromectol. For treatment of strongyloidiasis, the recommended dose for adults is a single oral dose of 15 mg (200 μg/kg). Ivermectin is also available in topical forms for therapy of rosacea and head lice. Oral ivermectin is generally well tolerated, but side effects can include diarrhea, gastrointestinal upset, headaches, fever, rash and itching, most of which are due to the effect of ivermectin on the helminth and a reaction to their death, release and expulsion.

In cell culture systems, ivermectin has activity against several viruses including the novel coronavirus known as Severe Acute Respiratory Syndrome coronavirus-type 2 (SARS-CoV-2), the cause of the global pandemic of respiratory illness that was first recognized in late 2019 (COVID-19). In face of the growing burden of severe illness posed by COVID-19, drugs with antiviral activity against SARS-CoV-2 in vitro were often tried (repurposed) to ameliorate the course and prevent mortality. Ivermectin was evaluated in several open label trials with suggestive evidence of benefit, but in more carefully designed, larger trials ivermectin in doses of 20 to 14 mg daily for 3 to 5 days had little or no effect in either preventing infection or ameliorating its outcome.

### Hepatotoxicity

Single dose therapy with ivermectin has been associated with a low rate of serum aminotransferase elevations. A single case of clinically apparent liver injury has been reported after ivermectin use (Case 1). The onset of injury occurred 1 month after a single dose and was characterized by a hepatocellular pattern of serum enzyme elevations without jaundice. Recovery was rapid and complete. In trials of ivermectin to prevent SARS-CoV-2 infection and to ameliorate the course of early as well as severe COVID-19, serum aminotransferase elevations were not uncommon but were no more frequent among patients receiving ivermectin than among those receiving placebo or a comparator drug.

Likelihood score: D (possible rare cause of mild clinically apparent liver injury).

### Mechanism of Injury

Ivermectin acts by interference with chloride channels that are important in neuromuscular activity in parasitic worms and protozoa, but has little activity against mammalian neural transmission. The mechanism by which it might cause liver injury is unknown.

### Outcome and Management

Ivermectin is usually well tolerated and the liver injury reported with its use has been mild and self-limited in course. Ivermectin has not been associated with acute liver failure or chronic liver injury.

Drug Class: Anthelmintic Agents

## CASE REPORT

### Case 1. Acute liver injury due to ivermectin.(1)

A 20 year old woman from the Cameroon who had been living in Switzerland for 5 years was found to have a migrating worm in her right sclera which was removed and identified as Loa loa. She had eosinophilia (18.5%) and microfilaremia and was treated with albendazole (600 mg daily) for 21 days. She subsequently had reduced but continued low levels of microfilia in the blood and three months later was treated with a single dose of ivermectin (15 mg orally). One month later, when seen for routine follow up, she complained of abdominal pain, and serum aminotransferase levels, which had been normal, were markedly elevated (Table). Serum bilirubin and alkaline phosphatase levels were normal. She had no history of liver disease or known risk factors for viral hepatitis other than country of origin. She did not drink alcohol and was not taking other medications, over-the-counter products or herbals. Tests for hepatitis A, B, and C and Epstein Barr virus infection were negative. A liver biopsy showed acute hepatocellular necrosis, apoptotic bodies, lymphocytic lobular infiltrates and no fibrosis. She improved clinically within days and serum aminotransferase levels fell rapidly, becoming normal three months later. Because of continuing low levels of microfilaremia, she was treated with diethylcarbamazine for 29 days with subsequent loss of microfilariae and no further problems or serum enzyme elevations.

#### Key Points

Medication: | Ivermectin (15 mg, single dose)
Pattern: | Hepatocellular (R=21.6)
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 1 month
Recovery: | 3 months
Other medications: | None in immediate previous 2 months

#### Laboratory Values

Time After Starting | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | 21 | 58 | 0.6 | Albendazole for 21 days
0 | 35 | 40 | 0.5 | Ivermectin one dose
1 month | 907 | 61 | 1.3
2 months | 111 | 57 | 1.0
3 months | 54 | 43 | 1.2
6 months | 13 | 38 | 0.8
Normal | <42 | <126 | <1.2

* Converted from μmol/L.

#### Comment

Without routine monitoring this mild case of anicteric hepatitis might have gone unrecognized. Because most studies of anthelmintic therapies have been done without routine monitoring of liver tests, the true rate of liver injury and even clinically apparent liver disease due to these agents may be underappreciated. On the other hand, this episode of acute hepatitis may have been due to an unrelated incurrent illness (hepatitis E for instance). Because the reaction occurred after a single dose of ivermectin, however, rechallenge would not be appropriate.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ivermectin – Generic, Stromectol®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ivermectin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ivermectin | 70288-86-7 | C48-H74-O14 and C47-H72-O14

## CITED REFERENCE

1 Veit O, Beck B, Steuerwald M, Hatz C. (2006). First case of ivermectin-induced severe hepatitis. Trans R Soc Trop Med Hyg.

## ANNOTATED BIBLIOGRAPHY

References updated: 09 April 2021

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; ivermectin is not discussed).
McCarthy J, Loukas A, Hotez PJ. Chemotherapy of helminth infections. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. Amsterdam: Elsevier, 2011, pp.1443-61. (Textbook of pharmacology and therapeutics; ivermectin is a semisynthetic avermectin, a novel class of macrocyclic lactones with activity against nematodes and arthropods and commonly used in veterinary medicine).
Shikiya K, Zaha O, Niimura S, Uehara T, Ohshiro J, Kinjo F, Saito A, et al. (1994). Kansenshogaku Zasshi. (Abstract only: among 125 patients with strongyloidiasis treated with ivermectin [6 mg, 2 oral doses 2 weeks apart], 14% had serum enzyme elevations, but all were self-limiting and asymptomatic).
Gardon J, Gardon-Wendel N. (1997). Cemanga-Ngangue, Kamgno J, Chippaux JP, Boussinesq M. Serious reactions after mass treatment of onchocerciasis with ivermectin in an area endemic for Loa loa infection. Lancet. (In a mass treatment program for onchocerciasis, 0.1% of 17,877 people treated developed severe reactions including neurological impairment and one death; reactions correlated with high pretreatment L. loa microfilaremia counts; no mention of jaundice or hepatitis).
Dunyo SK, Nkrumah FK, Simonsen PE. (2000). A randomized double-blind placebo-controlled field trial of ivermectin and albendazole alone and in combination for the treatment of lymphatic filariasis in Ghana. Trans R Soc Trop Med Hyg. (Placebo controlled trial of ivermectin, albendazole or the combination in 1425 persons from filariasis-endemic villages; showed clear reduction in microfilarial levels with ivermectin alone or in combination; side effects were mild and self-limited, no mention of liver injury).
Zaha O, Hirata T, Kinjo F, Saito A, Fukuhara H. (2002). Efficacy of ivermectin for chronic strongyloidiasis: two single doses given 2 weeks apart. J Infect Chemother. (50 patients with strongyloides infection were treated with two single doses of ivermectin; 98% efficacy and mild side effects only, 1 patient had minimal, transient ALT elevation [40 U/L]).
Guzzo CA, Furtek CI, Porras AG, Chen C, Tipping R, Clineschmidt CM, Sciberras DG, et al. (2002). Safety, tolerability, and pharmacokinetics of escalating high doses of ivermectin in healthy adult subjects. J Clin Pharmacol. (Multiple, escalating dose [30-120 mg] study of ivermectin; side effects were mild, transient and no more common than with placebo; 2% of 51 ivermectin- vs 6% of 17 placebo-recipients had transient ALT elevations [2-2.5 times ULN]).
Veit O, Beck B, Steuerwald M, Hatz C. (2006). First case of ivermectin-induced severe hepatitis. Trans R Soc Trop Med Hyg. (20 year old Cameroon woman with L. Loa infection developed symptoms and serum aminotransferase elevations 1 month after single dose of ivermectin [bilirubin 1.3 mg/dL, AL 907 U/L, Alk P 61 U/L], resolving in next 3 months: Case 1).
Sparsa A, Bonnetblanc JM, Peyrot I, Loustaud-Ratti V, Vidal E, Bédane C. (2006). Ann Dermatol Venereol. (72 year old man developed nausea and abdominal pain 3 days after single dose of ivermectin for scabies with ALT 2.5 times ULN, with resolution in 2 weeks; no mention of bilirubin).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, none were attributed to an anthelmintic agent).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to anthelmintic agents]).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, none of which were attributed to an anthelmintic agent).
(2013). Drugs for parasitic infections. Treat Guidel Med Lett. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects; ivermectin is useful in treatment of ascariasis, cutaneous larva migrans, filariasis, lice infestation, strongyloidiasis, and trichuriasis).
Muñoz J, Ballester MR, Antonijoan RM, Gich I, Rodríguez M, Colli E, Gold S, Krolewiecki AJ. (2018). Safety and pharmacokinetic profile of fixed-dose ivermectin with an innovative 18mg tablet in healthy adult volunteers. PLoS Negl Trop Dis. (Pharmacokinetic study compared fixed doses of ivermectin [16 or 32 mg] vs weight-based doses in 57 healthy volunteers, found equivalent plasma levels with all doses and there were no adverse events).
Barda B, Sayasone S, Phongluxa K, Xayavong S, Keoduangsy K, Odermatt P, Puchkov M, Huwyler J, Hattendorf J, Keiser J. (2017). Efficacy of moxidectin versus ivermectin against Strongyloides stercoralis infections: a randomized, controlled noninferiority trial. Clin Infect Dis. (Among 127 subjects with Strongyloides stercoralis infection treated with a single dose of moxidectin or ivermectin, response rates were 94% and 95%, adverse event rates were similar and "none of the participants reported any side effect from treatment at any time point").
Kircik LH, Del Rosso JQ, Layton AM, Schauber J. (2016). Over 25 Years of Clinical Experience With Ivermectin: An overview of safety for an increasing number of indications. J Drugs Dermatol. (Ivermectin has been used for more than 25 years for an expanding number of helminthic infections with an excellent safety profile both in humans and other mammals, probably because of its high specificity for invertebrate neuronal ion channels and because it does not cross the human blood-brain barrier; no mention of hepatotoxicity or ALT elevations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to ivermectin).
Ouédraogo AL, Bastiaens GJ, Tiono AB, Guelbéogo WM, Kobylinski KC, Ouédraogo A, Barry A, et al. (2015). Efficacy and safety of the mosquitocidal drug ivermectin to prevent malaria transmission after treatment: a double-blind, randomized, clinical trial. Clin Infect Dis. (Among 120 patients with Plasmodium falciparum infection given a single or repeated dose of artemether-lumefantrine with or without ivermectin, and no serious adverse events or "significant" biochemical abnormalities arose).
Caly L, Druce JD, Catton MG, Jans DA, Wagstaff KM. (2020). The FDA-approved drug ivermectin inhibits the replication of SARS-CoV-2 in vitro. Antiviral Res. (In cell culture, ivermectin was found to inhibit SARS-CoV-2 viral replication with greater than 90% decrease in viral RNA levels within 24 hours).
Schmith VD, Zhou JJ, Lohmer LRL. (2020). The approved dose of ivermectin alone is not the ideal dose for the treatment of COVID-19. Clin Pharmacol Ther. (Administration of ivermectin to experimental animals in doses of up to 10 times the approved dose in humans failed to achieve the concentrations in lung tissue that were associated with antiviral activity in cell culture, suggesting that higher doses would be needed to show an effect in human COVID-19 infection).
Rajter JC, Sherman MS, Fatteh N, Vogel F, Sacks J, Rajter JJ. (2021). Use of ivermectin is associated with lower mortality in hospitalized patients with coronavirus disease 2019: the ivermectin in COVID nineteen study. Chest. (Among 280 patients with COVID-19 in four Florida hospitals, prehospitalization administration of ivermectin [173 patients, typically given a single dose of 200 ug/kg] was associated with lower mortality [15% vs 25%] but similar durations of hospitalization; no mention of adverse events).
Szente Fonseca SN, de Queiroz Sousa A, Wolkoff AG, Moreira MS, Pinto BC, Valente Takeda CF, Rebouças E, et al. (2020). Risk of hospitalization for Covid-19 outpatients treated with various drug regimens in Brazil: Comparative analysis. Travel Med Infect Dis. (Among 3307 Northern Brazilian patients with confirmed COVID-19, the risk of hospitalization was less among those treated with prednisone or hydroxychloroquine or both, but not those treated with ivermectin compared to those who were not treated as outpatients; no mention of adverse events).
Camprubí D, Almuedo-Riera A, Martí-Soler H, Soriano A, Hurtado JC, Subirà C, Grau-Pujol B, et al. (2020). Lack of efficacy of standard doses of ivermectin in severe COVID-19 patients. PLoS One. (Outcomes of severe COVID-19 infection were similar among 13 hospitalized patients who were treated with a single dose of ivermectin to a matched untreated group; no mention of adverse events).
Ahmed S, Karim MM, Ross AG, Hossain MS, Clemens JD, Sumiya MK, Phru CS, et al. (2021). A five-day course of ivermectin for the treatment of COVID-19 may reduce the duration of illness. Int J Infect Dis. (Among 70 hospitalized patients with COVID-19, viral clearance was more rapid in those treated with 5 days of ivermectin alone [9.7 days] compared to placebo [12.7 days] or the combination of ivermectin and doxycycline [11.5 days], while duration of hospitalization and frequency of symptoms was similar; there were no serious adverse events and no deaths).
Pott-Junior H, Bastos Paoliello MM, Miguel AQC, da Cunha AF, de Melo Freire CC, Neves FF, da Silva de Avó LR, et al. (2021). Use of ivermectin in the treatment of Covid-19: A pilot trial. Toxicol Rep. (Among 30 hospitalized patients with COVID-19 treated with one of 3 doses of ivermectin [at an uncertain daily dose or duration] or with “standard of care”, the time to SARS-CoV-2 RNA negativity and rapidity of decline was similar in the three groups as were symptoms and adverse events; no mention of ALT levels and hepatotoxicity).
Chaccour C, Casellas A, Blanco-Di Matteo A, Pineda I, Fernandez-Montero A, Ruiz-Castillo P, Richardson MA, et al. (2021). The effect of early treatment with ivermectin on viral load, symptoms and humoral response in patients with non-severe COVID-19: A pilot, double-blind, placebo-controlled, randomized clinical trial. EClinicalMedicine. (Among 24 outpatients with recent onset of symptoms of COVID-19 treated with a single dose of ivermectin [400 µg/kg] or placebo, all 24 still had detectable viral RNA although in lower titers at day 7 and resolution of symptoms was similar, although slightly better in the ivermectin group).
Lima-Morales R, Méndez-Hernández P, Flores YN, Osorno-Romero P, Cuecuecha-Rugerio E, Nava-Zamora A, Hernández-Galdamez DR, et al. (2021). Effectiveness of a multidrug therapy consisting of Ivermectin, Azithromycin, Montelukast, and Acetylsalicylic acid to prevent hospitalization and death among ambulatory COVID-19 cases in Tlaxcala, Mexico. Int J Infect Dis. (Among 768 ambulatory adults with recent onset of COVID-19 symptoms, the 481 who received combination oral therapy with ivermectin [12 mg single dose], azithromycin [500 mg for 4 days] montelukast [for 21 days] and aspirin [for 30 days] were more likely to recover within 2 weeks [84% vs 59%] than patients not given this regimen, and were also less likely to be hospitalized [9% vs 31%] and to die [3% vs 18%], and “most participants did not experience any side effects”; no mention of ALT elevations or hepatotoxicity).
Behera P, Patro BK, Singh AK, Chandanshive PD, Ravikumar SR, Pradhan SK, Pentapati SSK, et al. (2021). Role of ivermectin in the prevention of SARS-CoV-2 infection among healthcare workers in India: A matched case-control study. PLoS One. (Among 186 healthcare workers in India who developed COVID-19 infection compared to 186 matched uninfected controls, ivermectin prophylaxis was more frequent in controls [41% vs 22%] and the difference was most evident in those who took two doses of ivermectin [300 mg 4 days apart], and there were no adverse side effects).
Babalola OE, Bode CO, Ajayi AA, Alakaloko FM, Akase IE, Otrofanowei E, Salu OB, et al. Ivermectin shows clinical benefits in mild to moderate COVID19: A randomised controlled double-blind, dose-response study in Lagos. QJM. 2021 Feb 18: hcab035. Epub ahead of print. (Among 62 patients with COVID-19 infection treated with ivermectin [6 or 12 mg every 84 hours] vs lopinavir/ritonavir, the days to viral RNA negativity was shorted with ivermectin [6.0 and 4.6 vs 9 days], but there were no differences in symptoms or outcomes of infection and no serious adverse events, while ALT and AST levels decreased slightly in all three groups while Alk P levels rose slightly).
López-Medina E, López P, Hurtado IC, Dávalos DM, Ramirez O, Martínez E, Díazgranados JA, et al. (2021). Effect of ivermectin on time to resolution of symptoms among adults with mild COVID-19: a randomized clinical trial. JAMA. (Among 400 patients with symptomatic but mild COVID-19 treated with ivermectin [300 mg daily] or placebo for 5 days, the time to resolution of symptoms was similar in the two groups [10 vs 12 days] as were adverse event rates [77% vs 81%] and serious adverse event rates [1% vs 1%], with no mention of ALT elevations or hepatotoxicity).
Galan LEB, Santos NMD, Asato MS, Araújo JV, de Lima Moreira A, Araújo AMM, Paiva ADP, et al. (2021). Phase 2 randomized study on chloroquine, hydroxychloroquine or ivermectin in hospitalized patients with severe manifestations of SARS-CoV-2 infection. Pathog Glob Health. (Among 168 Brazilian adults hospitalized with severe COVID-19 pneumonia who were treated with oral doses of chloroquine, hydroxychloroquine or ivermectin [10 or 14 mg for 3 days], the mortality rate was similar in all three groups [22%, 21% and 23%] as were adverse event rates including serum aminotransferase elevations [25% vs 22% vs 26%].

## OTHER REFERENCE LINKS

1 Recent References on Ivermectin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ivermectin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ivermectin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ivermectin)